# Oprelvekin

## OVERVIEW Oprelvekin [Interleukin-11]

### Introduction

Oprelvekin is a recombinant form of human interleukin 11, a cytokine that stimulates proliferation and maturation of bone marrow stem cells and megakaryocytes and is used to treat severe thrombocytopenia caused by chemotherapy. Interleukin 11 therapy has not been linked to serum enzyme elevations or with instances of jaundice or clinically significant acute liver injury.

### Background

Oprelvekin (oh prel' veh kin") is a recombinant DNA form of interleukin 11, a human cytokine produced by bone marrow stromal cells that induces the proliferation and maturation of hematopoietic stem cells and megakaryocytes. While it stimulates several bone marrow lineages in rodents, IL-11 effects in humans are largely upon megakaryocytes, stimulating a robust increase in platelet counts. Recombinant forms of interleukin 11 have been developed and shown to have potent thrombopoietic activity. Oprelvekin was approved for use in the United States in 1997 and current indications are as prevention of severe thrombocytopenia and need for platelet transfusions in adults receiving myelosuppressive chemotherapy of non-myeloid malignancies. Oprelvekin is available as lyophilized powder in single use vials of 5 mg under the brand name Neumega. The typical dose is 50 µg/kg subcutaneously once daily for 10 to 21 days, usually starting within 6 to 24 hours of completing chemotherapy. Common side effects include the complications of sodium retention such as peripheral edema, dyspnea, pleural effusions, dilutional anemia, tachycardia and atrial arrhythmias. Other side effects include headache, fever, dizziness and syncope. Less common but potentially severe adverse reactions include severe arrhythmias, allergic reactions and anaphylaxis, capillary leak syndrome, optic neuropathy, papilledema, visual disturbances and renal failure.

### Hepatotoxicity

In multiple controlled trials, interleukin 11 was not found to cause elevations in serum enzymes or episodes of clinically apparent liver injury. Furthermore, no specific instances of hepatitis or jaundice have been reported in the literature and liver injury is not listed as an adverse event in the product label. Thus, liver injury during interleukin-11 therapy must be rare, if it occurs at all.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism by which interleukin-11 infusions might cause liver injury is unclear as it is a recombinant human protein and thus is unlikely to have direct hepatotoxicity. Interleukin 11 does induce acute phase reactions in the liver and serum levels of fibrinogen and other proteins made in the liver may increase while expansion of the plasma volume may decrease serum albumin and hemoglobin levels.

### Outcome and Management

Serum enzyme elevations during oprelvekin therapy have not been reported or characterized. In situations in which ALT or AST levels rise and remain above 5 times ULN, dose modification or temporary discontinuation of the intravenous infusions is prudent.

Other cytokines used in cancer chemotherapy include interferon alfa, interferon beta and interferon gamma. Other agents used to treat thrombocytopenia include eltrombopag and romiplostim both of are thrombopoietin receptor agonists.

Drug Class: Thrombopoietin Receptor Agonists and Thrombopoiesis Stimulators, Cytokines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Oprelvekin – Neumega®

DRUG CLASS

Thrombopoietin Receptor Agonists and Thrombopoiesis Stimulators

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=oprelvekin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Oprelvekin | 145941-26-0 | Cytokine | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 08 June 2016

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of recombinant interleukin-11).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, Longo DL, Mitsiades C, Richardson P. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Tepler I, Elias L, Smith JW 2nd, Hussein M, Rosen G, Chang AY, Moore JO, et al. A randomized placebo-controlled trial of recombinant human interleukin-11 in cancer patients with severe thrombocytopenia due to chemotherapy. Blood 1996; 87: 3607-14. (Among 93 patients with severe thrombocytopenia due to cancer chemotherapy who were treated with IL-11 [25 or 50 µg/kg] or placebo subcutaneously once daily for 14-21 days, need for platelet transfusions were less with IL-11 therapy and "no evidence of direct liver or kidney toxicity was identified"). 8611684
Gordon MS. Thrombopoietic activity of recombinant human interleukin 11 in cancer patients receiving chemotherapy. Cancer Chemother Pharmacol 1996; 38 Suppl: S96-8. (Review of the mechanism of action and clinically efficacy of oprelvekin). 8765426
Isaacs C, Robert NJ, Bailey FA, Schuster MW, Overmoyer B, Graham M, Cai B, Beach KJ, Loewy JW, Kaye JA. Randomized placebo-controlled study of recombinant human interleukin-11 to prevent chemotherapy-induced thrombocytopenia in patients with breast cancer receiving dose-intensive cyclophosphamide and doxorubicin. J Clin Oncol 1997; 15: 3368-77. (Among 77 patients with breast cancer receiving intensive chemotherapy who were treated with IL-11 [50 µg/kg] or placebo injections daily for 10 or 17 days, IL-11 decreased the need for platelet transfusion and was "well tolerated", side effects being edema [63% vs 14%], dyspnea [48% vs 19%], pleural effusions [18% vs 0%], conjunctival injection [25% vs 0%]; no mention of ALT elevations or hepatotoxicity). 9363868
Recombinant interleukin-11 for chemotherapy-induced thrombocytopenia. Med Lett Drugs Ther 1998; 40 (1032): 77-8. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of oprelvekin shortly after its approval for use in the US; mentions side effects of sodium retention, edema, anemia, dyspnea, tachycardia and atrial arrhythmias, but does not mention ALT elevations or hepatotoxicity). 9706284
Kaye JA. FDA licensure of NEUMEGA to prevent severe chemotherapy-induced thrombocytopenia. Stem Cells 1998; 16 Suppl 2: 207-23. (Summary of medical evidence for safety and efficacy of oprelvekin supporting its FDA approval; mentions that changes in laboratory parameters during IL-11 therapy were limited to plasma proteins and red blood cells due to dilutional effects of sodium retention and stimulation of acute phase protein synthesis by the liver with increases in fibrinogen, ferritin, haptoglobin and C-reactive protein). 11012193
Moreland L, Gugliotti R, King K, Chase W, Weisman M, Greco T, Fife R, et al. Results of a phase-I/II randomized, masked, placebo-controlled trial of recombinant human interleukin-11 (rhIL-11) in the treatment of subjects with active rheumatoid arthritis. Arthritis Res 2001; 3: 247-52. (Among 91 patients with rheumatoid arthritis treated with 1 of 4 doses of IL-11 or placebo [once or twice weekly] for 12 weeks, disease activity was minimally improved but IL-11 was "well-tolerated"; adverse events included injection site reactions [61% vs 0%] and infections [8% vs 0%]; no mention of ALT elevations or hepatotoxicity). 11438043

## OTHER REFERENCE LINKS

1. Recent References on Oprelvekin [Interleukin 11]: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Oprelvekin%3Cbr%3E[Interleukin%2011]/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Oprelvekin [Interleukin 11]: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Oprelvekin%3Cbr%3E[Interleukin%2011])